# Macitentan

## OVERVIEW

### Introduction

Macitentan is an endothelin receptor antagonist that is used in the therapy of pulmonary arterial hypertension (PAH). Macitentan has been associated with a low rate of serum enzyme elevations during therapy, but has yet to be implicated in cases of clinically apparent acute liver injury.

### Background

Macitentan (ma" si ten' tan) is a nonselective inhibitor of the endothelin-1 receptors, both type A and B. Inhibition of endothelin receptors disrupts the intracellular pathways that lead to vasoconstriction, thus causing vasodilation. Because macitentan has high affinity for pulmonary endothelin receptors, it preferentially causes vasodilation in the pulmonary vasculature, thereby decreasing pulmonary vascular pressure. In prospective, randomized controlled trials, macitentan was effective in alleviating symptoms, improving exercise capacity and prolonging the time to clinical worsening in patients with idiopathic PAH. Macitentan was the third endothelin receptor antagonist to be approved in the United States (2013). The current indications are for symptomatic pulmonary arterial hypertension, classified as WHO group 1 (idiopathic). Use of macitentan in forms of PAH due to heart failure, thromboembolic disease or connective tissue disease should be considered experimental as its efficacy in these forms of PAH has not been adequately shown. Macitentan is available in tablets of 10 mg under the brand name Opsumit and the recommended dose is 10 mg once daily. Because of the potential for teratogenicity, macitentan is available for treating women only as a part of a risk evaluation and mitigation strategy (REMS) program in which documentation of adequate methods for birth control are required. Common side effects include headaches, dizziness, anemia, edema, flushing, rhinitis and dyspepsia that are frequent with most vasodilator therapies. Uncommon, but potentially severe adverse reactions include embryo-fetal toxicity, decrease in sperm counts, anemia and hypersensitivity reactions.

### Hepatotoxicity

Macitentan is associated with a low rate of serum aminotransferase elevations (0% to 4%) that, in clinical trials, was similar to the rate among placebo recipients. These elevations were usually mild, transient and not associated with symptoms, but were above 8 times the ULN in 2% of subjects (vs 0.4% of controls) in at least one long term study. For these reasons, the product label recommends that patients have serum enzymes tested before starting therapy and be alerted to the possibility and symptoms of liver injury during therapy. While there have been no published reports of clinically apparent liver injury with jaundice associated with macitentan, it has had limited general use. Other endothelin receptor antagonists (bosentan, sitaxentan) have been linked to several instances of acute liver injury, some of which have been severe. The onset of illness was usually within 1 to 6 months of starting bosentan and the enzyme pattern was typically hepatocellular or mixed. Immunoallergic features were not present and autoantibodies absent or present in low titer. Macitentan and ambrisentan have not been linked to similar cases.

Likelihood score: E* (unlikely but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which macitentan might cause liver injury is not known. Macitentan is metabolized by the cytochrome P450 system (CYP 2C9 and 3A4), which may lead to production of a toxic intermediate and can also cause drug-drug interactions, particularly with strong inducers or inhibitors of CYP 3A4. One possible reason for why macitentan is associated with a relatively low rate of ALT elevations and hepatotoxicity is its higher potency and lower daily dose (10 mg) in comparison to bosentan (125 to 250 mg).

### Outcome and Management

The serum enzyme elevations associated with macitentan use have been mild-to-moderate and self-limited in course, often resolving despite drug continuation. There is no information on cross sensitivity to hepatic injury among the various endothelin receptor antagonists.

Drug Class: Pulmonary Arterial Hypertension Agents

Other Drugs in the Class: Endothelin Receptor Antagonists: Ambrisentan (https://livertox.nlm.nih.gov//Ambrisentan.htm), Bosentan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Macitentan – Opsumit®

DRUG CLASS

Pulmonary Arterial Hypertension Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Macitentan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Macitentan | 441798-33-0 | C19-H20-Br2-N6-O4-S | Macitentan chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 30 September 2017

Abbreviations used: PAH, pulmonary arterial hypertension

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999, before the availability of endothelin receptor antagonists).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on drug induced liver injury; clinical features of liver injury due to the endothelin receptor antagonists are not specifically discussed).
Barnes PJ. Pharmacotherapy of pulmonary arterial hypertension. Pulmonary Pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1059-61. (Textbook of pharmacology and therapeutics).
Channick RN, Simonneau G, Sitbon O, Robbins IM, Frost A, Tapson VF, Badesch DB, et al. Effects of the dual endothelin-receptor antagonist bosentan in patients with pulmonary hypertension: a randomised placebo-controlled study. Lancet 2001; 358: 1119-23. (Controlled trial of bosentan [250 mg daily] vs placebo for at least 12 weeks in 32 patients with pulmonary arterial hypertension [PAH]; 2 of 21 patients receiving bosentan developed ALT elevations which resolved without need for discontinuation). 11597664
Galié N, Badesch D, Oudiz R, Simonneau G, McGoon MD, Keogh AM, Frost AE, et al. Ambrisentan therapy for pulmonary arterial hypertension. J Am Coll Cardiol 2005; 46: 529-35. (Among 64 patients with PAH treated with 1 of 4 doses of ambrisentan for 12 weeks, 3.1% developed ALT elevations above 3 times ULN and 2 patients discontinued therapy because of ALT values, but none had symptoms or jaundice). 16053970
Nagai Y, Okada E, Mihara S, Sato K, Ohi S, Ishikawa O. Severe liver dysfunction due to bosentan in a patient with mixed connective tissue disease. Eur J Dermatol 2008; 18: 190-1. (A 70 year old woman with connective tissue disease and digital ulcers developed ALT elevations [77 U/L] 2 months after starting bosentan, which rapidly worsened [ALT 3597 U/L, bilirubin and Alk P not given] despite stopping bosentan, and progressed to multiorgan failure and death within 2 weeks). 18424383
Galié N, Rubin Lj, Hoeper M, Jansa P, Al-Hiti H, Meyer G, Chiossi E, et al. Treatment of patients with mildly symptomatic pulmonary arterial hypertension with bosentan (EARLY study): a double-blind, randomised controlled trial. Lancet 2008; 371: 2093-100. (Controlled trial of bosentan [n=93] vs placebo [n=92] for 6 months in patients with PAH; serum ALT levels above 3 times ULN arose in 13% of bosentan- vs 2% of placebo-treated patients, mostly in first 20 weeks and resolving spontaneously in many without dose adjustment and without clinically apparent liver injury). 18572079
Galié N, Olschewski H, Oudiz RJ, Torres F, Frost A, Ghofrani HA, Badesch DB, et al.; Ambrisentan in Pulmonary Arterial Hypertension, Randomized, Double-Blind, Placebo-Controlled, Multicenter, Efficacy Studies (ARIES) Group. Ambrisentan for the treatment of pulmonary arterial hypertension: results of the ambrisentan in pulmonary arterial hypertension, randomized, double-blind, placebo-controlled, multicenter, efficacy (ARIES) study 1 and 2. Circulation 2008; 117: 3010-9. (Combined analysis of two controlled trials of different doses of ambrisentan vs placebo for 12 weeks in a total of 261 patients with PAH found that no patient developed ALT elevation above 3 times ULN). 18506008
Eriksson C, Gustavsson A, Kronvall T, Tysk C. Hepatotoxicity by bosentan in a patient with portopulmonary hypertension: a case-report and review of the literature. J Gastrointestin Liver Dis 2011; 20: 77-80. (A 29 year old woman developed jaundice 18 months after starting bosentan [bilirubin ~10 mg/dL, ALT 600 U/L, Alk P 480 U/L, INR 1.3], worsening for several weeks and then improving rapidly after starting prednisolone which ultimately could be withdrawn without relapse). 21451802
Raghu G, Million-Rousseau R, Morganti A, Perchenet L, Behr J; MUSIC Study Group. Macitentan for the treatment of idiopathic pulmonary fibrosis: the randomised controlled MUSIC trial. Eur Respir J 2013; 42: 1622-32. (Among 178 patients with pulmonary fibrosis treated with macitentan or placebo for one year, there were no differences in changes in lung function or time to worsening or death between the two groups, and serum ALT elevations above 3 times ULN occurred in 3.4% on macitentan vs 5% on placebo). 23682110
Pulido T, Adzerikho I, Channick RN, Delcroix M, Galiè N, Ghofrani HA, Jansa P, et al.; SERAPHIN Investigators. Macitentan and morbidity and mortality in pulmonary arterial hypertension. N Engl J Med 2013; 369: 809-18. (Among 742 patients with PAH treated with two doses of macitentan [3 or 10 mg daily] or placebo for one year, exercise tolerance was improved and time to clinical worsening delayed by macitentan, while side effects included headache, rhinitis and anemia; ALT elevations above 3 times ULN occurred in 3.4-3.6% of macitentan vs 4.5% of placebo recipients and were accompanied by bilirubin elevations in 1.7-2.1% vs 1.7%). 23984728
Macitentan (Opsumit) for pulmonary arterial hypertension. Med Lett Drugs Ther 2014; 56 (1436): 15-6. (Concise review of the mechanism of action, clinical efficacy, safety and costs of macitentan shortly after its approval for use in the US; mentions that rates of ALT elevations during macitentan therapy are no higher than with placebo, but elevations above 8 times ULN occurred in 2.1% with macitentan vs 0.4% with placebo). 24663031
Macías Saint-Gerons D, de la Fuente Honrubia C, Montero Corominas D, Catalá-López F. [Hepatotoxicity in patients treated with endothelin receptor antagonists: Systematic review and meta-analysis of randomized clinical trials.]. Med Clin (Barc) 2014; 142: 333-42. Spanish. (Systematic review of the literature, including 21 trials in 3644 patients, found relative risk of ALT or AST elevations above 3 times ULN to be 2.98 for endothelin receptor antagonists compared to placebo controls). 23540381
Hill NS, Badesch D, Benza RL, D'Eletto TA, Farber HW, Gomberg-Maitland M, Hassoun PM, Preston I. Perspectives on oral pulmonary hypertension therapies recently approved by the U.S. Food and Drug Administration. Ann Am Thorac Soc 2015; 12: 269-73. (Review of recently approved drugs for PAH including macitentan, riociguat and oral treprostinil; mentions that macitentan was not associated with a higher rate of serum enzyme elevations in comparison to placebo therapy, but that testing of serum enzymes before treatment is recommended and intermittent monitoring is prudent). 25590376
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one was attributed to bosentan, but none to macitentan or other agents used primarily to treat pulmonary artery hypertension). 25754159
Selej M, Romero AJ, Channick RN, Clozel M. Development of macitentan for the treatment of pulmonary arterial hypertension. Ann N Y Acad Sci 2015; 1358: 68-81. (Review of the clinical features, natural history, pathogenesis and therapy of PAH, and the development of macitentan, identified by modifying the molecular structure of bosentan and screening for high affinity for endothelin-1 receptor binding). 26291180
Tahara N, Dobashi H, Fukuda K, Funauchi M, Hatano M, Ikeda S, Joho S, et al. Efficacy and Safety of a novel endothelin receptor antagonist, macitentan, in Japanese patients with pulmonary arterial hypertension. Circ J 2016; 80: 1478-83. (Among 30 Japanese patients with PAH treated with macitentan for at least 6 months, exercise tolerance and pulmonary function improved, and ALT elevations occurred in only one patient [3%] compared to 16% of bosentan treated subjects monitored in Japanese postmarketing studies). 27180890
Wei A, Gu Z, Li J, Liu X, Wu X, Han Y, Pu J. Clinical adverse effects of endothelin receptor antagonists: insights from the meta-analysis of 4894 patients from 24 randomized double-blind placebo-controlled clinical trials. J Am Heart Assoc 2016; 5. pii: e003896. (Systematic review of 24 randomized trials of endothelin receptor antagonists indicated higher rates of "abnormal liver function" in patients receiving bosentan and macitentan, but not ambrisentan). 27912207
Safdar Z, Thakur A, Frost A. Tolerability of switch to macitentan from bosentan in pulmonary arterial hypertension. South Med J 2017; 110: 223-228. (Among 24 patients with PAH switched from bosentan to macitentan for unstated reasons, mean serum ALT and AST did not change although one patient had to stop macitentan because of ALT elevations). 28257550

## OTHER REFERENCE LINKS

1. Recent References on Macitentan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Macitentan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Macitentan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Macitentan)